# Lasmiditan

## OVERVIEW

### Introduction

Lasmiditan is a small molecule selective agonist of the serotonin 1F [5HT_1F_] receptor which decreases neuron activity that is thought to mediate pain and inflammation associated with migraine headaches. In clinical trials, lasmiditan was found to shorten the duration of migraine headache pain and other associated symptoms. Lasmiditan is generally well tolerated and has been associated with only rare instances of transient serum aminotransferase elevations during therapy but with no instances of clinically apparent liver injury.

### Background

Lasmiditan (las mid’ i tan) is a selective, small molecule agonist of the serotonin 1F [5-HT_1F_] receptor that leads to a decrease in neuronal electrical activity in trigeminal neurons which is associated with migraine headaches. Lasmiditan is highly selective for the 5-HT_1F_ receptor which is expressed on neurons in trigeminal ganglia and was developed as treatment of acute attacks of migraine with or without aura. In several randomized, placebo controlled trials, single doses of lasmiditan [50, 100 and 200 mg] increased the rate of being headache pain free 2 hours after dosing in comparison to placebo, as well as the rate of being free of the most bothersome other symptoms. Chronic therapy with lasmiditan had minimal effect in preventing migraine but it maintained its efficacy in treating acute episodes. Lasmiditan was approved for treatment of acute migraine with or without aura in adults in the United States in 2020, the first 5-HT_1F_ agonist approved for this indication. Lasmiditan is available in tablets of 50 and 100 mg with the brand name Reyvow. The recommended dose is 50, 100 or 200 mg orally as soon as possible after onset of migraine. The dose should not be repeated during any 24 hour period. Lasmiditan can be used by patients receiving preventive therapies for migraine, but is not approved for chronic use as a means of preventing migraine headaches. Lasmiditan has central nervous system side effects such as dizziness, impaired balance, somnolence, fatigue, sedation and impairment of driving (which should be avoided for at least 8 hours after dosing). Palpitations, bradycardia and increase in blood pressure can also occur, but severe adverse reactions are rare. Unlike triptans, which act on 5-HT_B/D_ receptors, lasmitidan does not induce vasoconstriction and can be used in patients with coronary artery disease. Rare but potentially serious adverse events include bradycardia (particularly with other drugs that slow the heart rate), the serotonin syndrome and hypersensitivity reactions with rash and angioedema.

### Hepatotoxicity

In preregistration controlled trials of lasmiditan in several thousand patients, mild-to-moderate serum aminotransferase elevations arose in a small percentage of patients (1% or less) and overall rates were not different from those in placebo recipients. In the controlled trials and subsequently with general use, there have been no reports of liver injury with symptoms or jaundice attributed to lasmiditan.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

Possible mechanisms of liver injury due to lasmiditan are not known. It is metabolized by multiple enzyme systems but does not have major CYP 450 interactions. It is generally given intermittently in single doses which may account for its relative freedom from major serious adverse events.

### Outcome and Management

Drug Class: Migraine Headache Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lasmiditan – Reyvow®

DRUG CLASS

Migraine Headache Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lasmiditan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Lasmiditan | 439239-90-4 | C19-H18-F3-N3-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 20 July 2021

Abbreviations: 5-HT, 5-hydroxytryptamine (serotonin).

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of lasmiditan).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/211280Orig1s000MedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA multidisciplinary scientific review of the lasmiditan application including specific discussion of hepatic adverse events, found similar low rates of significant serum ALT and AST elevations [<1%] with lasmiditan therapy as with placebo and concluded that there was no signal of hepatotoxicity identified).
Ferrari MD, Färkkilä M, Reuter U, Pilgrim A, Davis C, Krauss M, Diener HC, European COL-144 Investigators. (2010). Acute treatment of migraine with the selective 5-HT1F receptor agonist lasmiditan--a randomised proof-of-concept trial. Cephalalgia. (Among 130 patients with an acute migraine enrolled in a placebo controlled study of escalating doses of intravenous lasmiditan, improvements in headache pain occurred within 2 hours with single doses of 10, 20 and 45 mg and adverse events included dizziness, paresthesias and fatigue, but there were no serious adverse events and “no clinically significant changes in … clinical chemistry parameters”).
Färkkilä M, Diener HC, Géraud G, Láinez M, Schoenen J, Harner N, Pilgrim A, et al., COL MIG-202 study group. (2012). Efficacy and tolerability of lasmiditan, an oral 5-HT(1F) receptor agonist, for the acute treatment of migraine: a phase 2 randomised, placebo-controlled, parallel-group, dose-ranging study. Lancet Neurol. (Among 391 patients treated in a randomized controlled dose-finding trial for acute migraine with lasmiditan [5, 100, 200 or 400 mg] vs placebo, freedom from headache pain at 2 hours was achieved by more patients on higher doses of lasmiditan than placebo [14% to 28% vs 7%], but adverse events were more frequent with higher doses as well [65-86% vs 22%] including dizziness, fatigue, vertigo, paresthesias, somnolence and nausea).
Kuca B, Silberstein SD, Wietecha L, Berg PH, Dozier G, Lipton RB, COL MIG-301 Study Group. (2018). Lasmiditan is an effective acute treatment for migraine: A phase 3 randomized study. Neurology. (Among 1856 adults with an acute migraine attack in a randomized controlled trial, those treated with a single dose of lasmiditan [100 or 200 mg] were more likely to be headache pain free at 2 hours than those on placebo [28% and 32% vs 15%] and were more likely to be free of their most bothersome other symptom [41% and 41% vs 29.5%], and although overall adverse event rates were more frequent with drug [36% and 43% vs 16%], there were no drug related serious adverse events and “no clinically meaningful differences in … blood chemistry …across treatment groups”).
Goadsby PJ, Wietecha LA, Dennehy EB, Kuca B, Case MG, Aurora SK, Gaul C. (2019). Phase 3 randomized, placebo-controlled, double-blind study of lasmiditan for acute treatment of migraine. Brain. (Among 3005 patients treated in a randomized controlled trial, patients with an acute attack of migraine were more likely to be headache pain free two hours after receiving lasmiditan [50, 100 or 200 mg] than placebo [29%, 31% and 39% vs 21%] and more likely to be free of the other most bothersome symptom [41%, 44% and 49% vs 36%] but were also more likely to have an adverse event [25%; 36% and 39% vs 12%], although there “were no clinically meaningful differences in… blood chemistry… across the treatment groups).
Krege JH, Rizzoli PB, Liffick E, Doty EG, Dowsett SA, Wang J, Buchanan AS. (2019). Safety findings from Phase 3 lasmiditan studies for acute treatment of migraine: Results from SAMURAI and SPARTAN. Cephalalgia. (In a secondary analysis of adverse event rates from two large, randomized trials of oral lasmiditan [50, 100 or 200 mg; n=3177] versus placebo [n=1262] for acute migraine [Kuca 2018, Goadsby 2019], there were no deaths and serious adverse event rates were similar in all groups [0.2%], while there was a dose related increase in overall adverse event rates [13.5% with placebo vs 25%, 36% and 41% with lasmiditan] and “no significant differences in frequency of abnormal hepatic laboratory results” including serum ALT, AST, alkaline phosphatase and bilirubin levels).
Loo LS, Ailani J, Schim J, Baygani S, Hundemer HP, Port M, Krege JH. (2019). Efficacy and safety of lasmiditan in patients using concomitant migraine preventive medications: findings from SAMURAI and SPARTAN, two randomized phase 3 trials. J Headache Pain. (Post-hoc analysis of two large controlled trials of lasmiditan vs placebo for acute migraine [Kuca 2018, Goadsby 2019] for patients concurrently taking migraine preventive treatments [such as valproate, topiramate, beta-blockers, antidepressants, botulinum toxin type A and candesartan] had similar rates of clinical response as well as side effects as those not taking preventive treatments).
Brandes JL, Klise S, Krege JH, Case M, Khanna R, Vasudeva R, Raskin J, et al. (2019). Interim results of a prospective, randomized, open-label, Phase 3 study of the long-term safety and efficacy of lasmiditan for acute treatment of migraine (the GLADIATOR study). Cephalalgia. (Among 1978 patients with migraine headaches who participated in controlled trials of single doses of lasmiditan who were then enrolled in a long term open-label study of 100 vs 200 mg of lasmiditan for each new attack, clinical response rates and adverse event rates were similar to previous reports and overall “no pattern of clinically meaningful changes from baseline were observed in laboratory parameters”).
Lamb YN. (2019). Lasmiditan: first approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of lasmiditan shortly after its approval in the US, discusses common adverse events of dizziness, paresthesia, somnolence, nausea, fatigue, weakness and hypesthesia, and the rare instances of serotonin syndrome and hypersensitivity reactions, but does not mention ALT elevations or hepatotoxicity).
(2020). Lasmiditan (Reyvow) and ubrogepant (Ubrelvy) for acute treatment of migraine. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of ubrogepant and lasmiditan as therapy of acute migraine shortly after their approval for this indication in the US, mentions side effects of lasmiditan being dizziness, paresthesias, fatigue, nausea and somnolence but does not mention ALT elevations or hepatotoxicity).
(2020). Drugs for migraine. Med Lett Drugs Ther. (Concise summary of the relative clinical efficacy, safety and costs of drugs to treat acute migraine headache [such as analgesics, opiates, triptans, ergots and oral CGRP receptor antagonists] and to prevent migraines [such as anticonvulsants, beta blockers, antidepressants and the monoclonal antibodies to CGRP and its receptor]).
Ashina M, Reuter U, Smith T, Krikke-Workel J, Klise SR, Bragg S, Doty EG, et al. (2021). Randomized, controlled trial of lasmiditan over four migraine attacks: Findings from the CENTURION study. Cephalalgia. (Among 1471 patients with migraine headaches randomized to lasmiditan [50, 100 or 200 mg] vs placebo for up a 4 acute attacks, the response rate by dose was consistent over the four attacks while adverse event rates decreased; and “Overall, the changes in laboratory values were similar across treatment groups”).
Robbins MS. (2021). Diagnosis and management of headache: a review. JAMA. (Review of the diagnosis and management of headache including use of lasmiditan for acute migraine attacks which has side effects of dizziness, paresthesias, fatigue, nausea and somnolence, and patients should not drive or use heavy equipment for 8 hours after taking it; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Lasmiditan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lasmiditan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Lasmiditan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lasmiditan)